# Sodium-Glucose Cotransporter-2 (SGLT2) Inhibitors

## OVERVIEW

### Introduction

The sodium-glucose cotransporter-2 (SGLT2) inhibitors are diabetic agents that act by inhibiting the reabsorption of glucose in the proximal renal tubule, resulting in loss of glucose in the urine and reduction in serum levels. SGLT2 is the major enzyme responsible for glucose reabsorption in the kidney and its inhibition causes a reduction in the threshold for glucose loss in urine. The excess loss of glucose causes a loss of calories, reduction in serum glucose and mild osmotic diuresis. The SGLT2 inhibitors also cause a modest weight loss and slight decrease in blood pressure, both of which may contribute to their beneficial effects. Five specific SGLT2 inhibitors, bexagliflozin, canagliflozin, dapagliflozin, empagliflozin and ertugliflozin, have been shown to result in improvements in glycemic control in type 2 diabetes and introduced into clinical use. Canagliflozin, dapagliflozin and empagliflozin have also been shown to decrease cardiovascular complications and mortality in patients with type 2 diabetes and cardiovascular disease, and to reduce the risk of hospitalization for heart failure and development of end stage renal disease in patients with type 2 diabetes and chronic kidney disease. In prelicensure studies, none of the five agents was reported to be associated with increases in serum aminotransferase or alkaline phosphatase levels and, since licensure, there have been only very rare, isolated, and not completely convincing reports of clinically apparent liver injury associated with their use.

### Background

Bexagliflozin (bex’ a gli floe' zin) is a specific SGLT2 inhibitor that in clinical trials was shown to result in a reduction in serum HbA1c levels and better glycemic control in type 2 diabetes, both as monotherapy (in patients who failed to achieve adequate control on diet and exercise) or in combination with insulin, metformin and sulfonylureas. Bexagliflozin was approved for use in the United States in 2023 for management of hyperglycemia in patients with type 2 diabetes in conjunction with diet and exercise, with or without other antidiabetic medications. Bexagliflozin is available in tablets of 20 mg under the brand name Brenzavvy, the recommended dose being 20 mg once daily. Common side effects shared by all SGLT2 inhibitors include symptoms of thirst, urinary tract infections and mycotic genital infections. Less common side effects are hypersensitivity reactions, ketoacidosis, hypoglycemia, dehydration, hypovolemia and serum creatinine elevations. Bexagliflozin may be associated with an increased risk of lower limb amputations and necrotizing fasciitis of the perineum in patients with type 2 diabetes.

Canagliflozin (kan" a gli floe' zin) is a specific SGLT2 inhibitor that in clinical trials was shown to result in a reduction in serum HbA1c levels and improved glycemic control in type 2 diabetes, both as monotherapy (in patients who failed to achieve adequate control on diet and exercise) or in combination with insulin, metformin and/or sulfonylureas. Canagliflozin was approved for use in the United States in 2013 and current indications are for management of hyperglycemia in patients with type 2 diabetes in conjunction with diet and exercise, with or without other antidiabetic medications. After long term controlled trials, canagliflozin was also shown to reduce the risk of major adverse cardiovascular events (myocardial infarction, stroke and death) for patients with type 2 diabetes at risk for cardiovascular disease and was later shown to reduce the risk of end stage renal disease and hospitalization of heart failure for patients with diabetic nephropathy. For these reasons, canagliflozin is now recommended for these indications as well. Canagliflozin is available in tablets of 100 and 300 mg under the brand name Invokana, the recommended dose being 100 to 300 mg once daily. Combinations of canagliflozin including extended release forms with metformin are also available (Invokamet and Invokamet XR). Common side effects shared by all SGLT2 inhibitors include symptoms of thirst, urinary tract infections and mycotic genital infections. Less common side effects are hypersensitivity reactions, bone fractures, ketoacidosis, hypoglycemia, dehydration, hypovolemia and serum creatinine elevations. Canagliflozin may also be associated with an increased risk of lower limb amputations and necrotizing fasciitis of the perineum in patients with type 2 diabetes.

Dapagliflozin (dap' a gli floe' zin) is a specific SGLT2 inhibitor that has been shown to result in a reduction in serum HbA1c levels and better control of type 2 diabetes, both as monotherapy (in patients who failed to achieve adequate glycemic control on diet and exercise) or in combination with insulin, metformin and or sulfonylureas. Dapagliflozin was approved for use in the United States in 2014 and current indications are to improve glycemic control in patients with type 2 diabetes in conjunction with diet and exercise, with or without other antidiabetic medications. Long term therapy is also recommended for reduction in major cardiovascular outcomes (myocardial infarction, stroke, death), progression of renal disease and end stage renal failure, and hospitalization and death from heart failure in patients with type 2 diabetes at risk for these complications. Dapagliflozin is available in tablets of 5 and 10 mg under the brand name Farxiga, the recommended dose being 5 to 10 mg once daily. Fixed combinations of dapagliflozin with saxagliptin are available (Qtern) as are extended release combinations with metformin (Xigduo XR). Common side effects shared by all SGLT2 inhibitors include symptoms of thirst, urinary tract infections and mycotic genital infections. Less common side effects are hypersensitivity reactions, ketoacidosis, hypoglycemia, dehydration, hypovolemia and serum cholesterol and creatinine elevations. Dapagliflozin may also be associated with an increased risk of necrotizing fasciitis of the perineum in patients with type 2 diabetes.

Empagliflozin (em" pa gli floe' zin) is a specific SGLT2 inhibitor that in clinical trials was shown to result in a reduction in serum HbA1c levels and better glycemic control in type 2 diabetes, both as monotherapy (in patients who failed to achieve adequate control on diet and exercise) or in combination with insulin, metformin and or sulfonylureas. Empagliflozin was approved for use in the United States in 2014 for management of hyperglycemia in patients with type 2 diabetes in conjunction with diet and exercise, with or without other antidiabetic medications. In 2017, the indications for empagliflozin were extended to decrease the risk of cardiovascular death in adults with type 2 diabetes and cardiovascular disease, and later to decrease the risk of hospitalization or death from heart failure in adults with type 2 diabetes with heart failure. Empagliflozin is available in tablets of 10 and 25 mg under the brand name Jardiance, the recommended initial dose being 10 mg once daily, which can be increased to 25 mg daily. Fixed dose combinations of empagliflozin with metformin (Synjardy) and with linagliptin (Glyxambi) are also available. Common side effects shared by all SGLT2 inhibitors include symptoms of thirst, urinary tract infections and mycotic genital infections. Less common side effects are hypersensitivity reactions, ketoacidosis, hypoglycemia, dehydration, hypovolemia and serum creatinine elevations. Empagliflozin may also be associated with an increased risk of necrotizing fasciitis of the perineum in patients with type 2 diabetes.

Ertugliflozin (er" too gli floe' zin) is a specific SGLT2 inhibitor that in clinical trials was shown to result in a reduction in serum HbA1c levels and better glycemic control in type 2 diabetes, both as monotherapy (in patients who failed to achieve adequate control on diet and exercise) or in combination with insulin, metformin and sulfonylureas. Ertugliflozin was approved for use in the United States in 2018 for management of hyperglycemia in patients with type 2 diabetes in conjunction with diet and exercise, with or without other antidiabetic medications. Ertugliflozin is available in tablets of 5 and 15 mg under the brand name Steglatro, the recommended initial dose being 5 mg once daily, which can be increased to 15 mg daily. Fixed dose combinations of ertugliflozin with metformin (Segluromet) and with sitagliptin (Steglujan) are also available. Common side effects shared by all SGLT2 inhibitors include symptoms of thirst, urinary tract infections and mycotic genital infections. Less common side effects are hypersensitivity reactions, ketoacidosis, hypoglycemia, dehydration, hypovolemia and serum creatinine elevations. Ertugliflozin may be associated with an increased risk of lower limb amputations and necrotizing fasciitis of the perineum in patients with type 2 diabetes.

### Hepatotoxicity

In multiple large randomized controlled trials, canagliflozin, dapagliflozin, empagliflozin and ertugliflozin were not associated with serum enzyme elevations during therapy. Indeed, in retrospective analyses, therapy with SGLT2 inhibitors was associated with improvements in ALT levels, probably as a result of concurrent improvements in fatty liver disease due to improved glycemic control or weight loss or both. During prelicensure studies, no instances of clinically apparent acute liver injury were convincingly linked to use of the SGLT2 inhibitors, and serum enzyme elevations accompanied by jaundice occurred equally in the actively treated and placebo groups. Since their approval and more widespread use, at least one report of liver injury possibly due to a SGLT2 inhibitor has been published. A woman with nonalcoholic fatty liver disease and cirrhosis developed decompensation with jaundice, ascites and encephalopathy 10 weeks after starting dapagliflozin. She improved somewhat after stopping therapy, but ultimately required liver transplantation several months later. Thus, hepatotoxicity from canagliflozin, dapagliflozin, empagliflozin, ertugliflozin, and bexagliflozin is quite rare, if it occurs at all.

Bexagliflozin likelihood score: E (unlikely cause of clinically apparent liver injury).

Canagliflozin likelihood score: E (unlikely cause of clinically apparent liver injury).

Dapagliflozin likelihood score: D (possible rare cause of clinically apparent liver injury).

Empagliflozin likelihood score: E (unlikely cause of clinically apparent liver injury).

Ertugliflozin likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The relative lack of hepatotoxicity of the SGLT2 inhibitors may relate to their minimal hepatic metabolism which is largely via UDP-glucuronylsyltransferase (UGT-1A9 and 2B4 among others).

### Outcome and Management

Liver injury from the SGLT2 inhibitors is rare, and they have not been associated with acute liver failure, vanishing bile duct syndrome or chronic hepatitis. The similarity of structure and function of the SGLT2 inhibitors suggests that there may be some degree of cross sensitivity to their adverse events.

Drug Class: Antidiabetic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bexagliflozin – Brenzavvy®

Canagliflozin – Invokana®

Dapagliflozin – Farxiga®

Empagliflozin – Jardiance®

Ertugliflozin – Steglatro®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Canagliflozin) [Canagliflozin]

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bexagliflozin | 1118567-05-7 | C24-H29-Cl-O7
Canagliflozin | 928672-86-0 | C24-H25-F-O5-S.1/2H2-O
Dapagliflozin | 461432-26-8 | C21-H25-Cl-O6
Empagliflozin | 864070-44-0 | C23-H27-Cl-O7
Ertugliflozin | 1210344-57-2 | C22-H25-Cl-O7

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2023

Abbreviations: CAP, controlled attenuation parameter; GLP-1, glucagon-like peptide-1; HbA1c, hemoglobin A1c; SGLT2, sodium-glucose cotransporter-2.

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999 and before the availability of SGLT2 inhibitors).
De Marzio DH, Navarro VJ. Antidiabetic drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 528-32. (Review of hepatotoxicity of drugs for diabetes, does not discuss the SGLT2 inhibitors).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1248-67. (Textbook of pharmacology and therapeutics).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed SGLT2 inhibitors, which were rarely used during the period of this study).
Ferrannini E, Ramos SJ, Salsali A, Tang W, List JF. (2010). Dapagliflozin monotherapy in type 2 diabetic patients with inadequate glycemic control by diet and exercise: a randomized, double-blind, placebo-controlled, phase 3 trial. Diabetes Care. (Among 485 patients with type 2 diabetes who were not adequately controlled on diet and exercise advice were treated with one of 3 doses of dapagliflozin or placebo for 24 weeks, there was an increased incidence of signs and symptoms of urinary tract and genital infections on dapagliflozin: no mention of ALT levels of clinically apparent liver injury).
Wilding JP, Woo V, Soler NG, Pahor A, Sugg J, Rohwedder K, Parikh S, Dapagliflozin 006 Study Group. (2012). Long-term efficacy of dapagliflozin in patients with type 2 diabetes mellitus receiving high doses of insulin: a randomized trial. Ann Intern Med. (Among 805 patients with type 2 diabetes on insulin treated with dapagliflozin or placebo, those on dapagliflozin had higher rates of hypoglycemia episodes, genital and urinary tract infections, and weight loss [1.0-1.5 kg]; no discussion of ALT results or hepatotoxicity).
Tahrani AA, Barnett AH, Bailey CJ. (2013). SGLT inhibitors in management of diabetes. Lancet Diabetes Endocrinol. (Review of mechanisms of action, structure, pharmacokinetics, efficacy and safety of the SGLT inhibitors; no mention or discussion of ALT elevations or hepatotoxicity).
Vasilakou D, Karagiannis T, Athanasiadou E, Mainou M, Liakos A, Bekiari E, Sarigianni M, et al. (2013). Sodium-glucose cotransporter 2 inhibitors for type 2 diabetes: a systematic review and meta-analysis. Ann Intern Med. (Metaanalysis of publications on the safety and efficacy of the SGLT2 inhibitors states that: “regarding liver related adverse events, regulatory authorities’ reports concluded that slight imbalance among patients treated with dapagliflozin or canagliflozin and control groups were probably not associated with the study drug”).
Schernthaner G, Gross JL, Rosenstock J, Guarisco M, Fu M, Yee J, Kawaguchi M, et al. (2013). Canagliflozin compared with sitagliptin for patients with type 2 diabetes who do not have adequate glycemic control with metformin plus sulfonylurea: a 52-week randomized trial. Diabetes Care. (Among 756 patients treated with the addition of either canagliflozin or sitagliptin to stable therapy for 52 weeks, adverse events rates were similar in the two groups, except for higher rates of genital mycotic infections and small-to-moderate decreases in ALT, GGT and weight loss in the canagliflozin treated patients; no liver related serious adverse events in either group).
Stenlöf K, Cefalu WT, Kim KA, Alba M, Usiskin K, Tong C, Canovatchel W, et al. (2013). Efficacy and safety of canagliflozin monotherapy in subjects with type 2 diabetes mellitus inadequately controlled with diet and exercise. Diabetes Obes Metab. (Among 584 patients with type 2 diabetes treated with canagliflozin [200 or 300 mg] or placebo for 26 weeks, there were increased rates of urinary tract and genital infections and were modest improvements in ALT and Alk P levels).
(2013). Canagliflozin (Invokana) for type 2 diabetes. Med Lett Drugs Ther. (Concise overview on the use of canagliflozin in diabetes shortly after its approval for use in the US; mentions side effects of genital mycotic infections [10-15%], urinary tract infections [5%] and serum cholesterol elevations; no mention of hepatotoxicity or changes in serum ALT levels).
(2014). Dapagliflozin (Farxiga) for type 2 diabetes. Med Lett Drugs Ther. (Concise overview on the use of dapagliflozin in diabetes shortly after its approval for use in the US; mentions increased risk of mycotic genital infections and urinary tract infections, and its potential to cause hypovolemia and cholesterol elevations; no discussion of hepatotoxicity or serum ALT elevations).
(2014). Drugs for type 2 diabetes. Treat Guidel Med Lett. (Concise overview and recommendations on the use of medications in diabetes; the SGLT2 inhibitors can reduce HbA1c levels by 0.5-1.0% and cause mild weight loss).
Roden M, Weng J, Eilbracht J, Delafont B, Kim G, Woerle HJ, Broedl UC. (2013). EMPA-REG MONO trial investigators. Empagliflozin monotherapy with sitagliptin as an active comparator in patients with type 2 diabetes: a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Diabetes Endocrinol. (Among 899 patients with diabetes treated with empagliflozin at 2 doses, or sitagliptin, or placebo for 24 weeks; empagliflozin treated patients had more weight loss and higher rates of urinary tract and mycotic genital infections; no mention of ALT levels or hepatotoxicity).
Rosenstock J, Seman LJ, Jelaska A, Hantel S, Pinnetti S, Hach T, Woerle HJ. (2013). Efficacy and safety of empagliflozin, a sodium glucose cotransporter 2 (SGLT2) inhibitor, as add-on to metformin in type 2 diabetes with mild hyperglycaemia. Diabetes Obes Metab. (Among 495 patients with diabetes inadequately controlled on metformin treated with one of 5 doses of empagliflozin or sitagliptin or placebo for 12 weeks, adverse events included genital mycotic infections, urinary tract infections and frequent urination: no mention of ALT elevations or hepatotoxicity).
Häring HU, Merker L, Seewaldt-Becker E, Weimer M, Meinicke T, Broedl UC, Woerle HJ, EMPA-REG MET Trial Investigators. (2014). Empagliflozin as add-on to metformin in patients with type 2 diabetes: a 24-week, randomized, double-blind, placebo-controlled trial. Diabetes Care. (Among 638 patients with diabetes inadequately controlled on metformin treated with 2 doses of empagliflozin or placebo for 24 weeks, adverse events with empagliflozin included hypoglycemia [1-2%], urinary tract infections [5-6%] and genital infections [12%]; no mention of ALT elevations or hepatotoxicity).
Jahagirdar V, Barnett AH. (2014). Empagliflozin for the treatment of type 2 diabetes. Expert Opin Pharmacother. (Review of the safety and efficacy of empagliflozin based upon 2 published phase II and 4 phase III studies concluded that “empagliflozin was well tolerated”; no mention of ALT elevations or hepatotoxicity).
Ridderstråle M, Andersen KR, Zeller C, Kim G, Woerle HJ, Broedl UC. (2014). EMPA-REG H2H-SU trial investigators. Comparison of empagliflozin and glimepiride as add-on to metformin in patients with type 2 diabetes: a 104-week randomised, active-controlled, double-blind, phase 3 trial. Lancet Diabetes Endocrinol. (1549 patients with diabetes inadequately controlled on metformin, were randomly assigned to be treated with the addition of empagliflozin or glimepiride for 2 years; improvements in HbA1c and adverse events were both similar in both groups; reasons for discontinuation of empagliflozin included one case each of hepatic failure, acute hepatitis and jaundice with no further details; no mention of change in ALT levels).
(2014). Empagliflozin (Jardiance) for diabetes. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and cost of empagliflozin shortly after its approval for use in the US, states that adverse events include urinary tract and mycotic genital infections and dehydration; no mention of ALT elevations or hepatotoxicity).
Ptaszynska A, Johnsson KM, Parikh SJ, de Bruin TW, Apanovitch AM, List JF. (2014). Safety profile of dapagliflozin for type 2 diabetes: pooled analysis of clinical studies for overall safety and rare events. Drug Saf. (In a pooled analysis of 8685 patients from 12 controlled trials of dapagliflozin in type 2 diabetes, rates of adverse events were 17% vs 13% with placebo, including genital infections [11% vs 1%], urinary tract infections [6% vs 4%], polyuria [3% vs 1.7%] and liver test elevations [4% vs 4%]; mean ALT values decreasing by 3.9 U/L vs 1.7 U/L while combined liver enzyme and bilirubin elevations arose in 0.1% vs 0.2%).
Zinman B, Wanner C, Lachin JM, Fitchett D, Bluhmki E, Hantel S, Mattheus M, et al., EMPA-REG OUTCOME Investigators. (2015). Empagliflozin, cardiovascular outcomes, and mortality in type 2 diabetes. N Engl J Med. (Among 7020 patients with type 2 diabetes at high risk for cardiovascular disease treated with empagliflozin [10 or 25 mg] or placebo once daily for a median of 3.1 years, cardiovascular death rates were lower with the SGLT2 inhibitor therapy [3.7% vs 5.9%], while total and serious adverse event rates were similar in the 3 groups and no differences in changes from baseline of routine liver tests).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were at least possibly attributed to antidiabetic drugs, but none to SGLT2 inhibitors).
Leiter LA, Forst T, Polidori D, Balis DA, Xie J, Sha S. (2016). Effect of canagliflozin on liver function tests in patients with type 2 diabetes. Diabetes Metab. (Among 2313 patients with type 2 diabetes treated with canagliflozin or placebo for 26 weeks in 4 controlled trials, ALT, AST and Alk P levels decreased more with canagliflozin than placebo, but the decreases correlated more with reductions in HbA1c levels and weight rather than canagliflozin).
Storgaard H, Gluud LL, Bennett C, Grøndahl MF, Christensen MB, Knop FK, Vilsbøll T. (2016). Benefits and harms of sodium-glucose co-transporter 2 inhibitors in patients with type 2 diabetes: a systematic review and meta-analysis. PLoS One. (Systematic review of 18 controlled trials of SGLT2 inhibitors in type 2 diabetes found that SGLT2 inhibitors reduced ALT levels compared to placebo by an average of 2.8 U/L).
Levine JA, Ann Lo A, Wallia A, Rogers M, VanWagner LB. (2016). Dapagliflozin-induced acute-on-chronic liver injury. ACG Case Rep J. (A 48 year old woman with cirrhosis due to nonalcoholic steatohepatitis and type 2 diabetes developed jaundice and ascites 10 weeks after starting dapagliflozin [bilirubin 1.2 before treatment rising to 20 mg/dL, ALT 45 to 78 U/L, Alk P 220 to 188 U/L, INR 1.5, creatinine 0.8], improving somewhat when the drug was stopped, but qualifying for and then undergoing liver transplantation 4 months later).
Leiter LA, Forst T, Polidori D, Balis DA, Xie J, Sha S. (2016). Effect of canagliflozin on liver function tests in patients with type 2 diabetes. Diabetes Metab. (Among 2313 patients with type 2 diabetes enrolled in 6 placebo-controlled trials of canagliflozin, serum levels of ALT, AST, GGT and Alk P decreased with canagliflozin but not placebo and the degree of improvements correlated with both weight loss and improvements in HbA1c levels, an additive effect).
Neal B, Perkovic V, Mahaffey KW, de Zeeuw D, Fulcher G, Erondu N, Shaw W, et al., CANVAS Program Collaborative Group. (2017). Canagliflozin and cardiovascular and renal events in type 2 diabetes. N Engl J Med. (Among 10142 adults with type 2 diabetes at risk for cardiovascular disease treated with canagliflozin [100 or 300 mg] or placebo once daily for an average of 3.6 years in 2 randomized controlled trials, major cardiovascular events [death, myocardial infarction, stroke] were less with canagliflozin [26.9 vs 31.5 events per 1000 patient-years], while adverse event rates were similar except for lower extremity amputations [6.3 vs 3.4 per 1000 patient-years]; no mention of ALT elevations or hepatotoxicity).
Famularo G, Sajeva MR, Marino G, Granato C. (2017). Acute hepatitis caused by empagliflozin in a nonalcoholic fatty liver disease patient. Ann Pharmacother. (75 year old woman with type 2 diabetes developed fever and jaundice 6 weeks after starting empagliflozin [bilirubin 4.1 mg/dL, ALT 311 U/L, Alk P 587 U/L], which resolved within a week of stopping and remained normal thereafter, liver tests having been normal in the past despite having fatty liver by ultrasound).
Terra SG, Focht K, Davies M, Frias J, Derosa G, Darekar A, Golm G, et al. (2017). Phase III, efficacy and safety study of ertugliflozin monotherapy in people with type 2 diabetes mellitus inadequately controlled with diet and exercise alone. Diabetes Obes Metab. (Among 461 patients with type 2 diabetes treated with ertugliflozin [5 or 15 mg] or placebo daily for 26 weeks, improvements in glycemic control and weight loss were greater with active treatment while adverse event rates were no different from placebo except for genital mycotic infections; no mention of ALT levels or hepatotoxicity).
Miller S, Krumins T, Zhou H, Huyck S, Johnson J, Golm G, Terra SG, et al. (2018). Ertugliflozin and sitagliptin co-initiation in patients with type 2 diabetes: the VERTIS SITA randomized study. Diabetes Ther. (Among 291 patients with type 2 diabetes treated with the combination of ertugliflozin [5 or 15 mg] and sitagliptin [100 mg] or placebo daily, glycemic control was better and decreases in HbA1c greater with the active treatment, while adverse event rates were similar in all three groups; no mention of ALT elevations or hepatotoxicity).
Hollander P, Liu J, Hill J, Johnson J, Jiang ZW, Golm G, Huyck S, et al. (2018). Ertugliflozin compared with glimepiride in patients with type 2 diabetes mellitus inadequately controlled on metformin: the VERTIS SU randomized study. Diabetes Ther. (Among 1326 patients with type 2 diabetes inadequately controlled on metformin treated with the addition of ertugliflozin [5 or 15 mg] or glimepiride [~3 mg] daily, HbA1c decreases were similar in the 3 groups [-0.6 to -0.7%] and adverse event rates were similar except for higher rates of genital mycotic infections in patients on ertugliflozin; no mention of ALT elevations or hepatotoxicity).
Aronson R, Frias J, Goldman A, Darekar A, Lauring B, Terra SG. (2018). Long-term efficacy and safety of ertugliflozin monotherapy in patients with inadequately controlled T2DM despite diet and exercise: VERTIS MONO extension study. Diabetes Obes Metab. (Extension, open label assessment of ertugliflozin in diabetic patients enrolled in a placebo-controlled trial [Terra 2017], found that the improvements in glycemic control were maintained, and while mean levels of ALT and AST decreased, one patient on 5 mg daily of ertugliflozin had ALT and AST elevations "possibly related to study medication" with no details provided).
Pratley RE, Eldor R, Raji A, Golm G, Huyck SB, Qiu Y, Sunga S, et al. (2018). Ertugliflozin plus sitagliptin versus either individual agent over 52 weeks in patients with type 2 diabetes mellitus inadequately controlled with metformin: The VERTIS FACTORIAL randomized trial. Diabetes Obes Metab. (Among 1233 patients with type 2 diabetes inadequately controlled on metformin treated with ertugliflozin [5 or 15 mg] or sitagliptin [100 mg] or both, improvements in HbA1c and glycemic control were greatest with the combination, while adverse event rates were similar among groups except for higher rates of genital mycotic infections in those on ertugliflozin).
(2018). Ertugliflozin for type 2 diabetes. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ertugliflozin, the fourth SGLT2 inhibitor approved for use in the US; mentions side effects of genital mycotic infections and possible adverse reactions of hypovolemia, dehydration, renal injury, and increased risk for lower-limb amputations; no mention of ALT elevations or hepatotoxicity).
Markham A. (2018). Ertugliflozin: first global approval. Drugs. (Review of the mechanism of action, chemistry, pharmacology, clinical efficacy, and safety of ertugliflozin shortly after its US approval; mentions frequency of genital mycotic infections on treatment and that non-traumatic lower limb amputations occurred in 11 of 3409 [0.3%] ertugliflozin vs 1 of 1450 [<0.1%] comparator group patients; no mention of ALT elevations or hepatotoxicity).
Kuchay MS, Krishan S, Mishra SK, Farooqui KJ, Singh MK, Wasir JS, Bansal B, et al. (2018). Effect of empagliflozin on liver fat in patients with type 2 diabetes and nonalcoholic fatty liver disease: a randomized controlled trial (E-LIFT Trial). Diabetes Care. (Among 42 patients with type 2 diabetes and fatty liver treatment with empagliflozin was associated with greater decline in body weight [-3.3 vs -1.6 kg], ALT levels [-15 vs -4 U/L] and liver fat as assessed by magnetic resonance imaging [-5% vs -1%]).
Eriksson JW, Lundkvist P, Jansson PA, Johansson L, Kvarnström M, Moris L, Miliotis T, et al. (2018). Effects of dapagliflozin and n-3 carboxylic acids on non-alcoholic fatty liver disease in people with type 2 diabetes: a double-blind randomised placebo-controlled study. Diabetologia. (Among 84 patients with type 2 diabetes and fatty liver treated with dapagliflozin or n-3 carboxylic acids or both or placebo, ALT levels, HbA1c and body weight declined with dapagliflozin therapy whereas liver fat volume was decreased in all 3 active therapy groups).
Sattar N, Fitchett D, Hantel S, George JT, Zinman B. (2018). Empagliflozin is associated with improvements in liver enzymes potentially consistent with reductions in liver fat: results from randomised trials including the EMPA-REG OUTCOME® trial. Diabetologia. (Among 7020 patients with type 2 diabetes enrolled in a large, long term placebo-controlled trial of empagliflozin [Zinman 2015], serum ALT levels declined by week 28 by -3.0 U/L on empagliflozin vs -0.7 U/L on placebo and the changes were greatest in those with highest baseline ALT values).
Bajaj HS, Brown RE, Bhullar L, Sohi N, Kalra S, Aronson R. (2018). SGLT2 inhibitors and incretin agents: Associations with alanine aminotransferase activity in type 2 diabetes. Diabetes Metab. (Among 3667 diabetic patients enrolled in a health care registry and started on antidiabetic therapies, serum ALT levels deceased with canagliflozin [-4.3 U/L], dapagliflozin [-3.5], sitagliptin [-1.8], liraglutide [-2.1] but not in controls [-0.3], and the decreases in ALT correlated with weight loss, but was greater with the SGLT2 inhibitors than the incretin agents).
Choi DH, Jung CH, Mok JO, Kim CH, Kang SK, Kim BY. (2018). Effect of dapagliflozin on alanine aminotransferase improvement in type 2 diabetes mellitus with non-alcoholic fatty liver disease. Endocrinol Metab (Seoul). (Among 102 patients with type 2 diabetes and fatty liver disease started on metformin and either dapagliflozin or a dipeptidyl peptidase-4 inhibitor, ALT levels declined more with dapagliflozin [-21 vs -10 U/L] as did body weight [-2.9 vs -0.4 kg]).
Itani T, Ishihara T. (2018). Efficacy of canagliflozin against nonalcoholic fatty liver disease: a prospective cohort study. Obes Sci Pract. (Among 35 patients with nonalcoholic fatty liver treated with canagliflozin, serum ALT levels decreased from a mean of 74 to 40 U/L at 6 months with concurrent decrease in body weight [73 to 70 kg] and HbA1c [7.5% to 6.4%]).
Wiviott SD, Raz I, Bonaca MP, Mosenzon O, Kato ET, Cahn A, Silverman MG, et al., DECLARE–TIMI 58 Investigators. (2019). Dapagliflozin and cardiovascular outcomes in type 2 diabetes. N Engl J Med. (Among 17,160 patients with type 2 diabetes at risk for cardiovascular disease treated with dapagliflozin [10 mg] or placebo once daily for an average of 4.2 years, cardiovascular deaths and hospitalizations for heart failure were less with dapagliflozin, while discontinuations for adverse events were more common [8.1% vs 6.8%] as were genital infections [0.9% vs 0.1%] and diabetic ketoacidosis [0.3% vs 0.1%], but not amputations [1.4% vs 1.3%] or “hepatic events [both 1.0%]; no mention of ALT levels or hepatotoxicity).
Perkovic V, Jardine MJ, Neal B, Bompoint S, Heerspink HJL, Charytan DM, Edwards R, et al., CREDENCE Trial Investigators. (2019). Canagliflozin and renal outcomes in type 2 diabetes and nephropathy. N Engl J Med. (Among 4401 patients with diabetic nephropathy treated with canagliflozin [100 mg] of placebo daily for a median of 2.6 years, the risk of worsening of renal disease or death from renal or cardiovascular disease was reduced by canagliflozin, while adverse event rates were similar including low rates of “hepatic injury” [5.5 vs 6.5 per 1000 patient-years]; no mention of ALT elevations).
(2019). Cardiovascular benefits of SGLT2 inhibitors and GLP-1 receptor agonists in Type 2 diabetes. Med Lett Drugs Ther. (Concise update on the cardiovascular benefits of SGLT2 inhibitors and GLP-1 agonists mentions that long term therapy with canagliflozin and empagliflozin have been shown to reduce the risk of cardiovascular complications; no mention of hepatic adverse events).
Shimizu M, Suzuki K, Kato K, Jojima T, Iijima T, Murohisa T, Iijima M, et al. (2019). Evaluation of the effects of dapagliflozin, a sodium-glucose co-transporter-2 inhibitor, on hepatic steatosis and fibrosis using transient elastography in patients with type 2 diabetes and non-alcoholic fatty liver disease. Diabetes Obes Metab. (Among 57 patients with type 2 diabetes and fatty liver treated with dapagliflozin [5 mg daily] or standard therapy for 24 weeks, serum ALT levels decreased with dapagliflozin [38 to 26.5 U/L] as did liver fat [CAP 315 to 290 dB/m], with little or no change in either with standard treatment).
Halvorsen YD, Lock JP, Zhou W, Zhu F, Freeman MW. (2019). A 24-week, randomized, double-blind, active-controlled clinical trial comparing bexagliflozin with sitagliptin as an adjunct to metformin for the treatment of type 2 diabetes in adults. Diabetes Obes Metab. (Among 386 patients with type 2 diabetes with inadequate control on metformin given add on therapy for 24 weeks, there were similar improvements in HbA1c levels with bexagliflozin vs sitagliptin while total [71% vs 56%] and severe adverse event rates [3.7% vs 2.1%] were similar: no mention of ALT elevations or hepatotoxicity).
Halvorsen YC, Walford GA, Massaro J, Aftring RP, Freeman MW. (2019). A 96-week, multinational, randomized, double-blind, parallel-group, clinical trial evaluating the safety and effectiveness of bexagliflozin as a monotherapy for adults with type 2 diabetes. Diabetes Obes Metab. (Among 288 patients with type 2 diabetes treated with bexagliflozin or placebo for 96 weeks, HbA1c levels decreased with bexagliflozin but not with placebo, while adverse event rates were similar [including urinary tract infections and hypoglycemia] and a “hepatic” adverse event arose in one placebo- but no bexagliflozin-treated subject).
Halvorsen YD, Walford G, Thurber T, Russell H, Massaro M, Freeman MW. (2020). A 12-week, randomized, double-blind, placebo-controlled, four-arm dose-finding phase 2 study evaluating bexagliflozin as monotherapy for adults with type 2 diabetes. Diabetes Obes Metab. (Among 292 adults with type 2 diabetes treated with 3 different doses of bexagliflozin [5, 10 or 20 mg] or placebo daily for 12 weeks, there were dose related improvements in HbA1c and fasting blood glucose levels, and while total adverse event rates were similar with all 3 doses as with placebo, serious adverse events arose 5 bexagliflozin- but no placebo-treated subject: “assessment of the records of laboratory results…revealed no significant findings”).
Shi FH, Li H, Yue J, Jiang YH, Gu ZC, Ma J, Lin HW. Clinical adverse events of high-dose vs low-dose sodium-glucose cotransporter 2 inhibitors in type 2 diabetes: a meta-analysis of 51 randomized clinical trials. J Clin Endocrinol Metab. 2020; 105: dgaa586. (Metanalysis of 51 controlled trials of SGLT2 inhibitors for type 2 diabetes comparing 12,208 patients receiving high dose and 12,163 low dose therapy, overall and serious adverse event rates were similar and specific events mentioned infections, arthralgia, nausea, diarrhea, dizziness, creatinine elevations and hypoglycemia, but did not list or mention ALT elevations or hepatotoxicity).
(2022). Drugs for type 2 diabetes. Med Lett Drugs Ther. (Concise review of the safety and efficacy of drugs approved for treatment of type 2 diabetes mentions adverse effects of genital mycotic infections, urinary tract infections, volume depletion, acute kidney injury diabetic ketoacidosis, and possible risk of lower limb amputations and bone fractures; but does not mention ALT elevations or hepatotoxicity).
Halvorsen YD, Lock JP, Frias JP, Tinahones FJ, Dahl D, Conery AL, Freeman MW. (2023). A 96-week, double-blind, randomized controlled trial comparing bexagliflozin to glimepiride as an adjunct to metformin for the treatment of type 2 diabetes in adults. Diabetes Obes Metab. (Among 426 adults with type 2 diabetes with an inadequate response to metformin who received add on therapy with bexagliflozin [20 mg] or glimepiride [titrated] for 96 weeks, improvements in HbA1c levels were similar with both drugs, but episodes of hypoglycemia [17% vs 33%] were less with bexagliflozin, average body weight decreased [-3.75 kg vs +0.65 kg] and mean ALT levels improved [-4 U/L vs +1 U/L]; “hepatobiliary” adverse events occurred in 2.3% vs 2.8% of subjects).
Koshino A, Oshima M, Arnott C, Fletcher RA, Bakris GL, Jardine M, Mahaffey KW, et al. (2023). Effects of canagliflozin on liver steatosis and fibrosis markers in patients with type 2 diabetes and chronic kidney disease: A post hoc analysis of the CREDENCE trial. Diabetes Obes Metab. (Among 4387 patients with diabetic nephropathy treated with canagliflozin [100 mg] vs placebo daily for a median of 2.6 years, noninvasive measures of hepatic steatosis improved, and measures of hepatic fibrosis worsened less with canagliflozin, while ALT and AST levels did not differ between the two arms).

## OTHER REFERENCE LINKS

1 Recent References on SGLT2 Inhibitors: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=SGLT-2+Inhibitors+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on SGLT2 Inhibitors: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=SGLT-2)